# Ginkgo

## OVERVIEW

### Introduction

Ginkgo is a popular herbal medication and extract derived from the leaves and seeds of the tree Ginkgo biloba. Ginkgo has not been implicated in causing liver injury.

### Background

Ginkgo (ging' koe) is a widely used herbal derived from the leaves and seeds of the Ginkgo biloba tree, a “living fossil”, being the only extant species of what was a large order of plants (Ginkgoales) more than 200 million years ago. Ginkgo is native to central China, but has been introduced worldwide. The word ginkgo derives from a Japanese approximation of the Chinese word for “silver apricot” referring to the tree’s fruit. Extracts from ginkgo leaves and seeds were used in traditional Chinese medicine for centuries for a multitude of illnesses and conditions. Ginkgo extracts contain multiple compounds, but ginkgolides and bilobalide are unique to this herb. Ginkgo extracts have been shown to have antioxidant, antiinflammatory and antihistaminic activity. Current uses are many and include dementia, memory loss, headache, dizziness, tinnitus, hearing problems, difficulty concentrating, mood disturbances, peripheral vascular disease, asthma, and bronchitis. Ginkgo is purported to increase mental acuity and delay the effects of aging on the brain, as well as improve peripheral circulation, prevent macular degeneration and decrease symptoms of claudication and Raynaud’s syndrome. Ginkgo leaf extract is also used in foods, cosmetics, and skin lotions. The scientific bases for the purported effects of ginkgo are not well established and clinical trials have shown no or only modest clinical effects in dementia, claudication and tinnitus. Ginkgo is available in a variety of formulations (tablets, capsules, powder, teas, and lotions) and the typical oral dosage is 120 to 240 mg per day in 2 to 3 divided doses. Side effects of ginkgo are uncommon and mild, and include gastrointestinal upset, nausea, diarrhea, headache, dizziness, increased bleeding tendency and rash. In clinical trials, both serious and common side effects have been no more frequent with ginkgo than placebo.

### Hepatotoxicity

Despite wide spread use, ginkgo has not been specifically linked to liver injury, either in the form of transient serum enzyme elevations or clinically apparent acute liver injury. Indeed, ginkgo is sometimes used to treat acute or chronic liver injury. Gingko demostrates some degree of inhibition of cytochrome P450 activity in vitro, but in doses used in humans it appears to have little effect on drug metabolism. Several instances of excessive bleeding during therapy with ginkgo have been attributed to drug interactions with antiplatelet medications or anticoagulants.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Maidenhair tree, fossil tree, kew tree, Japanese silver apricot

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ginkgo – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/ginkgo/ataglance.htm)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ginkgo | 90045-36-6 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 14 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; ginkgo is not discussed).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; ginkgo is listed as nonhepatotoxic).
Ginkgo. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 371-84. (Compilation of short monographs on herbal medications and dietary supplements).
Kleijnen J, Knipschild P. Ginkgo biloba. Lancet 1992; 340: 1136-9. (Review of history, mechanism of action, clinical and adverse effects of ginkgo; “no serious side effects have been noted in any trial”; rarely, there are mild gastrointestinal complaints, headaches or allergic skin reactions). 1359218
De Smet PAGM. Herbal remedies. N Engl J Med 2002; 347: 2046-56. (Review of status and difficulties of herbal medications, including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort). 12490687
Sierpina VS, Wollschlaeger B, Blumenthal M. Ginkgo biloba. Am Fam Physician 2003; 68: 923-6. (Ginkgo is used in the treatment of cerebrovascular disease and dementia and is generally well tolerated, but can increase risk of bleeding when used in combination with antiplatelet therapy or anticoagulants). 13678141
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity; ginkgo is not listed as causing hepatotoxicity). 12879994
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to ginkgo). 15390328
Naik SR, Panda VS. Antioxidant and hepatoprotective effects of Ginkgo biloba phytosomes in carbon tetrachloride-induced liver injury in rodents. Liver Int 2007; 27: 393-9. (In rats, ginkgo extract decreased the toxic injury induced by carbon tetrachloride, decreased free radical oxidative stress and increased glutathionine, superoxide dismutase and glutathione reductase levels). 17355462
Yuan G, Gong Z, Li J, Li X. Ginkgo biloba extract protects against alcohol-induced liver injury in rats. Phytother Res 2007; 21: 234-8. (Ginkgo extract decreased steatosis and inflammation and serum ALT levels in a rat model of alcohol liver injury, which was likely mediated by a decrease in oxidative stress and prevention of glutathione depletion). 17154234
Sener G, Omurtag GZ, Sehirli O, Tozan A, Yüksel M, Ercan F, Gedik N. Protective effects of ginkgo biloba against acetaminophen-induced toxicity in mice. Mol Cell Biochem 2006; 283: 39-45. (Ginkgo extracts decreased cell injury, ALT and TNFα levels in a mouse model of acetaminophen hepatotoxicity perhaps mediated by its antioxidant activity). 16444584
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals but none attributed to ginkgo). 19159172
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were attributed to ginkgo). 18955056
DeKosky ST, Williamson JD, Fitzpatrick AL, Kronmal FA, Ives DG, Saxton JA, Lopez OL, et al. Ginkgo biloba for prevention of dementia: a randomized controlled trial. JAMA 2008; 300: 2253-62. (Controlled trial of long term [median 6.1 years] administration of ginkgo vs placebo in ~3000 elderly patients with no or mild impairment of cognition, showing no effect in preventing dementia; “The adverse event profiles for G. biloba and placebo were similar and there were no statistically significant differences in the rates of serious adverse events”). 19017911
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; ginkgo is not listed as a potentially hepatotoxic botanical). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 52 related to ginkgo [6.7%], including 2 reports of serum enzyme elevations; no details given). 19650152
Fransen HP, Pelgrom SM, Stewart-Knox B, de Kaste D, Verhagen H. Assessment of health claims, content, and safety of herbal supplements containing Ginkgo biloba. Food Nutr Res 2010; 54. (Efficacy and safety of Ginkgo leaf products found little support for health claims, variability in the content of Ginkgo components and concern about drug-herb interactions particularly in coagulation). 20927202
Ihl R, Bachinskaya N, Korczyn AD, Vakhapova V, Tribanek M, Hoerr R, Napryeyenko O; on behalf of the GOTADAY Study Group. Efficacy and safety of a once-daily formulation of Ginkgo biloba extract EGb 761 in dementia with neuropsychiatric features: a randomized controlled trial. Int J Geriatr Psychiatry 2011; 26: 1186-94. (Controlled trial of ginkgo [240 mg once daily] vs placebo in 410 patients with suspected Alzheimer's disease or vascular dementia for at least 24 weeks; adverse event rates were similar for both groups and no liver related events were reported). 21140383
Herrschaft H, Nacu A, Likhachev S, Sholomov I, Hoerr R, Schlaefke S. Ginkgo biloba extract EGb 761® in dementia with neuropsychiatric features: a randomised, placebo-controlled trial to confirm the efficacy and safety of a daily dose of 240 mg. J Psychiatr Res 2012; 46: 716-23. (Controlled trial of ginkgo [240 mg once daily] vs placebo in 410 patients with suspected Alzheimer's disease or vascular dementia for at least 24 weeks; no hepatic adverse events were reported and "...laboratory tests did not reveal any conspicuous or systematic changes"). 22459264
Diamond BJ, Bailey MR. Ginkgo biloba: indications, mechanisms, and safety. Psychiatr Clin North Am 2013; 36: 73-83. (Review of results of clinical trials of ginkgo focusing largely on EGb 761, a standardized product used in Europe given in doses of 80 to 240 mg daily; side effects have included bleeding abnormalities perhaps due to antiplatelet activity and interactions with warfarin; no mention of hepatotoxicity). 23538078
Unger M. Pharmacokinetic drug interactions involving Ginkgo biloba. Drug Metab Rev 2013; 45: 353-85. (Extensive review of evidence for drug interactions by ginkgo concludes that interactions are minimal with standard doses of gingko). 23865865
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to ginkgo). 23419359
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea extract, but none to ginkgo containing products). 24918129
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to ginkgo). 25043597
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products mentions that ginkgo biloba can interact with warfarin and aspirin and affect platelet function, increasing the risk of abnormal bleeding). 25500423
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were primarily attributed to ginkgo: see Navarro [2014]). 25754159
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products does not include ginkgo in the listings]). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26950122) (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against commercial products when reports of liver injury appeared in postmarketing phase).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention ginkgo). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, but none were attributed specifically to ginkgo). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity; ginkgo is not included as a potential cause of liver injury). 27842768
Pawar RS, Handy SM, Cheng R, Shyong N, Grundel E. Assessment of the authenticity of herbal dietary supplements: comparison of chemical and DNA barcoding methods. Planta Med 2017; 83: 921-36. (Chemical and DNA barcoding methods were applied to 112 marketed samples of herbal supplements and among 20 labelled as ginkgo, all had evidence of ginkgolides but 16 samples had evidence of contamination with other flavonoid-rich extracts). 28454189
Li S, Zhang X, Fang Q, Zhou J, Zhang M, Wang H, Chen Y, et al. Ginkgo biloba extract improved cognitive and neurological functions of acute ischaemic stroke: a randomised controlled trial. Stroke Vasc Neurol 2017; 2: 189-97. (Among 348 Chinese adults with recent onset of an acute ischemic stroke treated with ginkgo biloba extract or placebo for up to 6 months, adverse events were uncommon and similar in the two groups including results of 'the laboratory evaluation"). 29507779
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically mentioning ginkgo). 28555362

## OTHER REFERENCE LINKS

1. Recent References on Ginkgo: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ginkgo+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ginkgo: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ginkgo)